# Teriflunomide

## OVERVIEW

### Introduction

Teriflunomide is an orally available immunomodulatory agent used to treat relapsing multiple sclerosis. Teriflunomide is associated with transient serum enzyme elevations during therapy and with rare instances of clinically apparent acute liver injury.

### Background

Teriflunomide (ter" i floo' noe mide) is the active metabolite of leflunomide, an immunomodulatory agent similar to thalidomide, and is used in the treatment of multiple sclerosis. The mechanism of action of teriflunomide appears to be based, at least in part, upon inhibition of the enzyme dihydro-orotate dehydrogenase, which is an important step in pyrimidine synthesis. The activation and proliferation of lymphocytes are dependent upon pyrimidine synthesis and is acutely sensitive to its inhibition, resulting in suppression of ongoing immune reactivity. Teriflunomide has other activities including inhibition of NF-kappa B pathways that may contribute to its immunomodulatory actions. In animal models of multiple sclerosis, teriflunomide was shown to have beneficial effects which led to its critical evaluation in this disease. In several large, randomized controlled trials, teriflunomide was found to reduce relapse rates and improve neuro-radiologic outcomes in adult patients with relapsing-remitting multiple sclerosis. Teriflunomide was approved for use for multiple sclerosis in the United States in 2012 and is now available in tablets of 7 and 14 mg generically and under the brand name Aubagio. The recommended dose in adults is 7 or 14 mg orally once daily. Common side effects are headache, diarrhea, nausea, paresthesia, arthralgia, neutropenia, hypertension, and hair loss (alopecia). Rare, but potentially serious adverse events include bone marrow suppression, increased risk of severe infections, liver injury, peripheral neuropathy, reactivation of tuberculosis, serious skin reactions, hypersensitivity reactions, and embryofetal toxicity.

### Hepatotoxicity

In large randomized controlled trials of teriflunomide, serum ALT elevations occurred in 13% to 15% of teriflunomide compared to 9% of placebo recipients. Elevations above 3 times the upper limit of normal occurred in 6% of teriflunomide versus 4% of placebo recipients, usually within the first 6 months of therapy. The enzyme elevations were usually transient and not associated with symptoms or jaundice, but led to drug discontinuation in 2% to 3% of patients. The abnormalities resolved rapidly with drug discontinuation and resolved spontaneously in at least half of patients without drug modification. During preregistration trials, a single case of severe liver injury with jaundice was described, ALT elevations appearing 5 months after starting teriflunomide. Because of this and the known hepatotoxic potential of leflunomide, teriflunomide was given a "black box" warning regarding hepatotoxicity, and routine monitoring of liver tests is recommended monthly for the first 6 months and intermittently thereafter. Since approval and more wide scale usage, there have been at least six cases of clinically apparent liver injury published in the medical literature and the current package label mentions instances of severe hepatitis and fatal hepatic failure as possible adverse events. Clinically apparent liver injury also occurs with leflunomide, generally presenting with a hepatocellular or mixed pattern of serum enzyme elevations within 1 to 6 months of starting therapy. Immunoallergic and autoimmune features have not been prominent in most cases although single instances of DRESS syndrome have been reported. As with teriflunomide, rare cases of acute liver failure and death have been reported with leflunomide. The clinical features of the liver injury reported with leflunomide are similar to those that occur with teriflunomide.

Likelihood score: C (probable rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which teriflunomide might cause liver injury is not known. It is extensively metabolized by the liver largely by the cytochrome P450 system (largely CYP2C8) and is susceptible to drug-drug interactions, particularly with warfarin, oral contraceptives and agents that are metabolized by CYP 2C8 (paclitaxel, pioglitazone) and possibly others.

### Outcome and Management

While chronic therapy with teriflunomide can be associated with mild-to-moderate serum aminotransferase elevations, it has only rarely been linked to cases of clinically apparent liver injury. Nevertheless, monitoring of liver tests before starting teriflunomide therapy and monthly for the first 6 months of treatment followed by intermittently thereafter is recommended. In instances of suspected teriflunomide toxicity, elimination of the drug can be accelerated by cholestyramine or activated charcoal. Teriflunomide is eliminated slowly from the serum probably due to enterohepatic recirculation. Without an accelerated elimination procedure using activated charcoal (50 g every 12 hours for 11 days) or cholestyramine (8 grams every 8 hours for 11 days), drug levels can remain elevated for months. Cross sensitivity to hepatic injury is likely between teriflunomide and leflunomide as well as thalidomide, but there have been no reports of cross sensitivity with other disease-modifying agents used to treat multiple sclerosis such as glatiramer acetate, dimethyl fumarate, fingolimod or interferon beta.

Drug Class: Multiple Sclerosis Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Teriflunomide – Generic, Aubagio®

DRUG CLASS

Multiple Sclerosis Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Teriflunomide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Teriflunomide | 163451-81-8 | C12-H9-F3-N2-O

## ANNOTATED BIBLIOGRAPHY

References updated: 20 September 2025

Abbreviations used: ULN, upper limit of the normal range
Zimmerman HJ. Oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 697-8. (Expert review of hepatotoxicity published in 1999 before the availability of teriflunomide).
Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013. (Multi-authored textbook of hepatotoxicity published in 2013 does not discuss the drugs for multiple sclerosis).
Krensky AM, Azzi JR, Hafler DA. Immunotherapy for multiple sclerosis. Immunosuppressants and tolerogens. In, Brunton LL, Hilal-Dandan, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 649-652. (Textbook of pharmacology and therapeutics).
O'Connor PW, Li D, Freedman MS, Bar-Or A, Rice GP, Confavreux C, Paty DW, Stewart JA, et al.; Teriflunomide Multiple Sclerosis Trial Group; University of British Columbia MS/MRI Research Group. A Phase II study of the safety and efficacy of teriflunomide in multiple sclerosis with relapses. Neurology 2006; 66: 894-900. (Among 179 patients with multiple sclerosis treated with teriflunomide [7 or 14 mg daily] or placebo for 36 weeks, ALT elevations occurred in 12-16% of teriflunomide vs 10% of placebo treated patients, but rates of discontinuation because of liver test abnormalities were similar in all groups). 16567708
O'Connor P, Wolinsky JS, Confavreux C, Comi G, Kappos L, Olsson TP, Benzerdjeb H, et al.; TEMSO Trial Group. Randomized trial of oral teriflunomide for relapsing multiple sclerosis. N Engl J Med 2011; 365: 1293-303. (Among 1088 patients with relapsing multiple sclerosis treated with teriflunomide [7 or 14 mg daily] or placebo for 2 years, relapse rates were lower, but ALT elevations were more common with teriflunomide [54% and 57%] than placebo [36%], although elevations above 3 times the ULN were similar in all groups [~6.5%] and no patient developed clinically apparent liver injury attributable to treatment). 21991951
Gold R. Oral therapies for multiple sclerosis: a review of agents in phase III development or recently approved. CNS Drugs 2011; 25: 37-52. (Review of oral medications for multiple sclerosis under development, including dimethyl fumarate [BG-12], fingolimod, teriflunomide, laquinimod and cladribine, mentions that ALT elevations are more frequent with teriflunomide than placebo treatment so that monitoring of liver enzymes during therapy is recommended). 21128693
Killestein J, Rudick RA, Polman CH. Oral treatment for multiple sclerosis. Lancet Neurol 2011; 10: 1026-34. (Review of the clinical usefulness and safety of 5 new oral therapies for relapsing multiple sclerosis mentions that liver enzyme elevations can occur with teriflunomide and fingolimod therapy). 22014437
Confavreux C, Li DK, Freedman MS, Truffinet P, Benzerdjeb H, Wang D, Bar-Or A, et al; Teriflunomide Multiple Sclerosis Trial Group. Long-term follow-up of a phase 2 study of oral teriflunomide in relapsing multiple sclerosis: safety and efficacy results up to 8.5 years. Mult Scler. 2012; 18: 1278-89. (Among 147 patients enrolled in clinical trials of teriflunomide who were entered into an open label extension study, mild elevations in ALT levels were common occurring in ~63% of patients, but were above 3 times ULN in only 12%, but no elevation was associated with symptoms or jaundice). 22307384
New drugs for relapsing multiple sclerosis. Med Lett Drugs Ther 2012; 54 (1403): 89-91. (Concise review of efficacy, safety and costs of new disease modifying drugs for multiple sclerosis lists side effects in a table including "transaminase elevations" for interferon beta, fingolimod and teriflunomide, and "hepatotoxicity" for natalizumab, but not for glatiramer or mitoxantrone). 23183318
Brunetti L, Wagner ML, Maroney M, Ryan M. Teriflunomide for the treatment of relapsing multiple sclerosis: a review of clinical data. Ann Pharmacother 2013; 47: 1153-60. (Systematic review of 6 phase II and III trials of teriflunomide in relapsing multiple sclerosis reports ALT elevations above 3 times ULN in 12-14% of teriflunomide vs 7% of control subjects; no mention of clinically apparent liver injury). 24259730
Garnock-Jones KP. Teriflunomide: a review of its use in relapsing multiple sclerosis. CNS Drugs 2013; 27: 1103-23. (Review of the structure, mechanism of action, clinical efficacy and safety of teriflunomide in relapsing multiple sclerosis, mentions that ALT elevations are more frequent with teriflunomide than placebo, but are generally mild and asymptomatic with only a few cases having an accompanying elevation in bilirubin, rates being no higher with teriflunomide than with placebo; most ALT elevations occurred during the first year of therapy and, in half, the elevations returned to normal without stopping treatment). 24198223
Oh J, O'Connor PW. Safety, Tolerability, and Efficacy of Oral Therapies for Relapsing-Remitting Multiple Sclerosis. CNS Drugs 2013; 27: 591-609. (Review of efficacy and safety or oral agents for multiple sclerosis, including fingolimod, teriflunomide, dimethyl fumarate, laquinimod and cladribine, none of which have raised major issues of hepatotoxicity). 23801528
Miller AE, Wolinsky JS, Kappos L, Comi G, Freedman MS, Olsson TP, Bauer D, Benamor M, Truffinet P, O'Connor PW; TOPIC Study Group. Oral teriflunomide for patients with a first clinical episode suggestive of multiple sclerosis(TOPIC): a randomised, double-blind, placebo-controlled, phase 3 trial. Lancet Neurol 2014; 13: 977-86. (Among 614 patients with early multiple sclerosis treated with teriflunomide [7 or 14 mg daily] or placebo for up to 2 years, relapse rates were less while ALT elevations above 3 times ULN were more frequent with teriflunomide [12%] than placebo [9.5%], and there were no cases of clinically apparent liver injury). 25192851
Confavreux C, O'Connor P, Comi G, Freedman MS, Miller AE, Olsson TP, Wolinsky JS, et al.; TOWER Trial Group. Oral teriflunomide for patients with relapsing multiple sclerosis(TOWER): a randomised, double-blind, placebo-controlled, phase 3 trial. Lancet Neurol 2014; 13 (3): 247-56. (Among 1169 patients with relapsing multiple sclerosis treated with teriflunomide [7 or 14 mg daily] or placebo for at least 48 weeks, the relapse rate was decreased, but ALT elevations occurred in 8% of teriflunomide and 6% of placebo-treated subjects; two patients developed jaundice with ALT elevations, and all recovered with discontinuation). 24461574
Pawate S, Bagnato F. Newer agents in the treatment of multiple sclerosis. Neurologist 2015; 19: 104-17. (Summary of the efficacy and safety of new drugs for multiple sclerosis mentions that fingolimod, laquinimod and teriflunomide have been associated with serum enzyme elevations during treatment, but no specifics given). 25888198
Papadopoulou A, Kappos L, Sprenger T. Safety of teriflunomide for the management of relapsing-remitting multiple sclerosis. Expert Opin Drug Saf 2015; 14: 749-59. (Review of the mechanism of action, efficacy and safety of teriflunomide in relapsing multiple sclerosis states that ALT elevations were more frequent with teriflunomide [11% to 14%] than placebo [7% to 8%], but that the elevations were mostly mild and asymptomatic, and rates of severe elevations and those accompanied by bilirubin increases were the same with teriflunomide as with placebo). 25687236
English C, Aloi JJ. New FDA-approved disease-modifying therapies for multiple sclerosis. Clin Ther 2015; 37: 691-715. (Systematic review of efficacy and safety of the newer disease modifying therapies of multiple sclerosis lists ALT elevations as adverse events associated with fingolimod, teriflunomide and dimethyl fumarate, but not peginterferon beta or alemtuzumab). 25846320
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-1352. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 7 [0.8%] were attributed to interferon beta, but none were linked to teriflunomide or other drugs used for multiple sclerosis). 25754159
Feinstein A, Freeman J, Lo AC. Treatment of progressive multiple sclerosis: what works, what does not, and what is needed. Lancet Neurol 2015; 14: 194-207. (Commentary on management of progressive multiple sclerosis in which most of the newer disease modifying agents have little effect, mentions that major attention should be paid to management and relief of symptoms such as fatigue, bladder dysfunction, spasticity, pain, depression and cognitive dysfunction; no discussion of liver related adverse effects). 25772898
O'Connor P, Comi G, Freedman MS, Miller AE, Kappos L, Bouchard JP, Lebrun-Frenay C, et al.; Teriflunomide Multiple Sclerosis Oral (TEMSO) Trial Group and the MRI-AC in Houston, Texas. Long-term safety and efficacy of teriflunomide: Nine-year follow-up of the randomized TEMSO study. Neurology 2016; 86: 920-30. (Among 742 patients with multiple sclerosis treated with teriflunomide for up to 9 years in an extension study after a controlled trial [O'Connor 2011], 25 patients [2.8% to 3.8%] developed ALT elevations above 3 times the ULN and discontinued therapy and 2 had concurrent increases in bilirubin, although other causes were found in both). 26865517
Ancello S, Goliel T, Reddy S. Toxicity in the treatment: the first reported case of DILI induced by multiple sclerosis drug teriflunomide. Am J Gastro 2017;112:S1279-80. Not in PubMed. (37 year old woman with multiple sclerosis developed fatigue and jaundice 6 months after starting teriflunomide [bilirubin 9.0 mg/dL, ALT 1498 U/L, Alk P 159 U/L] resolving after discontinuation).
Filippi M, Bar-Or A, Piehl F, Preziosa P, Solari A, Vukusic S, Rocca MA. Multiple sclerosis. Nat Rev Dis Primers. 2018;4:43.. (Review of the pathogenesis, clinical features, natural history, management and therapy of multiple sclerosis). 30410033
Antonazzo IC, Poluzzi E, Forcesi E, Riise T, Bjornevik K, Baldin E, Muratori L, et al. Liver injury with drugs used for multiple sclerosis: a contemporary analysis of the FDA Adverse Event Reporting System. Mult Scler. 2019;25:1633-1640.. (Analysis of reports of liver injury to the FDA Adverse Events Reporting System between 2004 and 2016 suggested that the disease modifying agents for multiple sclerosis that appear to have hepatotoxic potential include interferon beta, teriflunomide, fingolimod, mitoxantrone and alemtuzumab, whereas glatiramer, dimethyl fumarate, and natalizumab do not). 30230957
LeSaint KT, Waksman J, Smolin CG. A case of teriflunomide-induced hepatic injury: assessing causality using available rules. Toxicol Communications 2020;4:62-66. Not in PubMed (48 year old man with multiple sclerosis developed fever and jaundice shortly after starting teriflunomide [bilirubin 6.2 mg/dL, ALT 478 U/L, Alk P 236 U/L] with rapid improvement on stopping and treatment with cholestyramine).
Choudhary R, Ashraf R, Thakur V, Kumaran MS. Teriflunomide-induced drug reaction with eosinophilia and systemic symptoms (DRESS) syndrome. Clin Exp Dermatol. 2021;46:166-169.. (27 year old woman with multiple sclerosis developed fever, rash, and facial edema 3 weeks after starting teriflunomide [ALT 3827 U/L, bilirubin and Alk P not given, eosinophils 1600/μL], with improvement on stopping and prednisolone and cholestyramine therapy but severe relapse when she stopped corticosteroid therapy and subsequent death from refractory septic shock). 32557734
Kingwell E, Zhang T, Zhu F, Walld R, Carruthers R, Evans C, Marrie RA, et al. Short-term laboratory and related safety outcomes for the multiple sclerosis oral disease-modifying therapies: an observational study. Expert Opin Drug Saf. 2021;20:481-487.. (Among 1,140 patients placed on a disease modifying drug for multiple sclerosis between 2011 and 2016 in two Canadian provinces, de novo elevations in ALT arose in 12% of those on teriflunomide compared to 13% on dimethyl fumarate and 30% on fingolimod). 33342303
Nehzat N, Mirmosayyeb O, Barzegar M, Vosoughi R, Fazeli E, Shaygannejad V. Comparable Efficacy and safety of teriflunomide versus dimethyl fumarate for the treatment of relapsing-remitting multiple sclerosis. Neurol Res Int. 2021;2021:6679197.. (Among 159 Iranian patients with relapsing-remitting multiple sclerosis treated with either teriflunomide or dimethyl fumarate the matched cohorts had similar annualized relapse rates and adverse event rates [81% vs 88%] and “liver dysfunction” rates [15% vs 15%] while only 1 patient taking teriflunomide discontinued therapy because of “abnormal liver function”). 34336283
Mian P, van Haaften WT, Assink M, van Drie-Pierik RJHM. Acute teriflunomide overdose with relatively mild symptoms: A case report. J Clin Pharm Ther. 2021;46:1784-1786.. (37 year old man with multiple sclerosis took an overdose of teriflunomide [672 mg: 48 tablets] along with cocaine and alcohol but suffered only mild headache and polyuria and blood testing revealed normal complete blood counts as well as liver and kidney tests). 33421160
Kappos L, Fox RJ, Burcklen M, Freedman MS, Havrdová EK, Hennessy B, Hohlfeld R, et al. Ponesimod compared with teriflunomide in patients with relapsing multiple sclerosis in the active-comparator phase 3 OPTIMUM Study: a randomized clinical trial. JAMA Neurol. 2021;78:558–67.. (Among 1133 adults with relapsing multiple sclerosis treated with oral ponesimod [20 mg] or teriflunomide [14 mg] once daily for up to 2 years, the annualized relapse rate was lower with ponesimod [0.2 vs 0.3] and overall adverse event rates were similar [89% vs 88%], while ALT elevations were more frequent with ponesimod [any elevation 20% vs 9%, elevation above 3 times ULN in 17% vs 8%, and resulting in discontinuation in 9% vs 6%], yet no patient developed clinically apparent acute liver injury with jaundice). 33779698
Drugs for multiple sclerosis. Med Lett Drugs Ther. 2021;63(1620):42–8.. (Concise review of the relative clinical efficacy, safety and costs of drugs for relapsing multiple sclerosis including parenteral agents [such as interferon-beta, glatiramer acetate, natalizumab, alemtuzumab, ocrelizumab, ofatumumab, rituximab and mitoxantrone] and the oral agents [such as the S1P receptor modulators, cladribine, fumarates, and teriflunomide], many of which are associated with serum ALT elevations and several have been reported to cause clinically apparent liver injury or reactivation of hepatitis B). 33976089
Biolato M, Bianco A, Lucchini M, Gasbarrini A, Mirabella M, Grieco A. The disease-modifying therapies of relapsing-remitting multiple sclerosis and liver injury: a narrative review. CNS Drugs. 2021;35:861-880.. (Extensive review of the frequency and characteristics of hepatic injury associated with different disease modifying drugs for multiple sclerosis, mentions that in controlled trials, teriflunomide therapy was associated with ALT elevations in 31% of patients that were above 5 times ULN in 2%, while discontinuations for liver injury were uncommon [3% to 4%], and since approval there have been no published cases of teriflunomide induced liver injury). 34319570
Ferreira CM, Vasconcelos-Pereira EF, Oliveira VM, Salgado PR, Domingos JA, Monreal MTFD, Guerra-Shinohara EM, et al. Hepatotoxicity associated with the use of teriflunomide in a patient with multiple sclerosis: A case report. Medicine (Baltimore). 2021;100:e28246.. (44 year old Brazilian woman with multiple sclerosis developed abdominal pain and nausea 48 days after starting teriflunomide [bilirubin 1.2 mg/dL, ALT 1384 U/L, GGT 690 U/L], with prompt improvement on discontinuation, later tolerating glatiramer). 34941096
Wurzburger R. A case of delayed hepatic injury associated with teriflunomide use as assessed for causality using the updated RUCAM. Case Reports Hepatol. 2022;2022:6331923.. (60 year old woman with multiple sclerosis developed jaundice 9 months after starting teriflunomide [bilirubin 2.5 rising to 10.9 mg/dL, ALT 777 U/L, Alk P 478 rising to 972 U/L] with resolution of jaundice within a month of stopping but Alk P was still elevated [355 U/L]). 35756947
Montalban X, Vermersch P, Arnold DL, Bar-Or A, Cree BAC, Cross AH, Kubala Havrdova E, et al.; evolution RMS investigators. Safety and efficacy of evobrutinib in relapsing multiple sclerosis (evolutionRMS1 and evolutionRMS2): two multicentre, randomised, double-blind, active-controlled, phase 3 trials. Lancet Neurol. 2024;23:1119-1132.. (Among 2290 adults with relapsing multiple sclerosis treated in two control trials of evobrutinib vs teriflunomide, the annualized relapse rate was similar in both arms [15% vs 14%] as were adverse event rates [86% vs 87%], including elevated ALT rates [15% vs 18%] although elevations above 5 times ULN within 12 weeks was higher with evobrutinib [5% vs <1%] as were combined elevations of bilirubin and ALT levels [in 3 vs 1 patient]). 39307151
Ng HS, Zhu F, Zhao Y, Yao S, Lu X, Ekuma O, Evans C, Fisk JD, Marrie RA, Tremlett H. Adverse Events associated with disease-modifying drugs for multiple sclerosis: a multiregional population-based study. Neurology. 2024;102:e208006.. (Among 35,894 people from 4 Canadian provinces with multiple sclerosis and available health data there was an increased risk for incident chronic liver disease in patients on teriflunomide and acute liver injury in those on dimethyl fumarate). 38181306
Dumitru-Martoiu MM, Petrescu S, Panea CA. Etiopathogenic and therapeutic considerations in a multiple sclerosis case with acute toxic hepatitis. Reports (MDPI). 2025;8:38.. (39 year old woman with multiple sclerosis on long-term natalizumab [7 years] and ashwagandha for weight loss [1 month] took 4 to 5 tablets of acetaminophen [unknown dose] for 5 days for a upper respiratory infection and presented with jaundice and ecchymoses [bilirubin 7.6 mg/dL, ALT 2120 U/L, Alk P 247 U/L, R~25] with rapid recovery and normal ALT one week later). 40710829
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102.. (Among 483 cases of drug-induced liver injury enrolled in a prospective Latin American database, one case was attributed to fingolimod and one to natalizumab, but no other agents used to treat multiple sclerosis were listed: personal communication). 38992407

## OTHER REFERENCE LINKS

1. Recent References on Teriflunomide: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Teriflunomide+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Teriflunomide: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Teriflunomide)